# Pravastatin

## OVERVIEW

### Introduction

Pravastatin is a commonly used cholesterol lowering agent (statin) that is associated with mild, asymptomatic and self-limited serum aminotransferase elevations during therapy, and rarely with clinically apparent acute liver injury.

### Background

Pravastatin (pra" va stat' in) is an orally available inhibitor of hepatic 3-hydroxy-3-methylglutaryl-coenzyme A (HMG-CoA) reductase, the major rate-limiting enzyme in cholesterol synthesis. Like other members of its class (the “statins”), pravastatin lowers total serum cholesterol and low densitylipoprotein (LDL) concentrations, thereby reducing the risk of atherosclerosis and its complications – myocardial infarction and stroke. Pravastatin was approved for use in the United States in 1991 and continues to be widely used with more than 9 million prescriptions filled yearly. Current indications are for treatment of hypercholesterolemia in persons at high risk for coronary, cerebrovascular and peripheral artery disease. Pravastatin is available in tablets of 10, 20, 40 and 80 mg in several generic forms and under the brand name of Pravachol. The recommended dose in adults is 40 to 80 mg once daily. Common side effects include muscle cramps, joint aches, abdominal pain, nausea, headache and weakness, symptoms that occur with all of the currently available statins. Rare but potentially severe adverse events include liver injury, myopathy, rhabdomyolysis, and immune-mediated necrotizing myopathy.

### Hepatotoxicity

Pravastatin therapy is associated with mild, asymptomatic and usually transient serum aminotransferase elevations. In summary analyses of large scale studies with prospective monitoring, ALT elevations above normal occurred in 3% to 7% of patients; but levels above 3 times the upper limit of normal (ULN) occurred in less than 1.2% of both pravastatin- as well as in placebo-treated subjects. Most of these elevations were self-limited and did not require dose modification. Pravastatin has been only rarely associated with clinically apparent hepatic injury with symptoms or jaundice at a rate estimated to be 1 per 100,000 users or less. In the case reports, latency varied from 2 to 9 months and the pattern of serum enzyme elevations from cholestatic to hepatocellular. Recovery was complete within a few months. Rash, fever and eosinophilia were uncommon as were autoantibodies, but few cases have been reported and the full clinical syndrome not well defined. Pravastatin appears to be less likely to cause clinically apparent liver injury than atorvastatin, simvastatin and rosuvastatin.

Likelihood score: B (likely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of hepatic injury from pravastatin is unknown. Pravastatin has only minimal hepatic metabolism and most is excreted unchanged in the urine. The mild, self-limited ALT elevations may be due to production of a minor toxic intermediate of metabolism and the reversal of these elevations due to adaptation. The idiosyncratic, clinically apparent liver injury associated with pravastatin may be due to immune mediated responses.

### Outcome and Management

The product labels for most statins recommend screening for liver test abnormalities before starting therapy and repeating tests as clinically indicated. The mild ALT elevations associated with pravastatin therapy are usually self-limited and do not require dose modification, although pravastatin should be stopped if ALT levels rise above 10-fold the ULN, or persist in being above 5-fold elevated or are associated with symptoms. In the clinically apparent liver injury attributed to pravastatin, recovery was usually complete within 1 to 2 months. In view of the wide scale use of pravastatin, clinically apparent and severe liver injury is extraordinarily rare. Recurrence of injury with rechallenge has been reported and should be avoided. Switching therapy to another statin after pravastatin induced injury can lead to recurrence and should be done with careful monitoring.

Drug Class: Antilipemic Agents

Other Drugs in the Subclass, Statins: Atorvastatin, Ezetimibe [used in combination], Fluvastatin, Lovastatin, Pitavastatin, Rosuvastatin, Simvastatin

## CASE REPORT

### Case 1. Acute cholestatic hepatitis attributed to pravastatin therapy.(1)

A 57 year old man developed abdominal pain and nausea followed by fever and jaundice 6 weeks after starting pravastatin (20 mg daily) for long standing hypercholesterolemia. He had a history of coronary artery disease and had been treated with beta blockers and various cholesterol lowering drugs, including fenofibrate and simvastatin in the past. At the time of presentation, he was taking only pravastatin and metoprolol, both of which were discontinued promptly. He denied alcohol use and had no risk factors for viral hepatitis. Physical examination showed jaundice and hepatic tenderness but no rash, fever, or signs of chronic liver disease. Laboratory results showed a cholestatic pattern of serum enzyme elevations and hyperbilirubinemia (Table). Tests for hepatitis A, B and C were negative as were autoantibodies. Ultrasound and CT of the abdomen showed no evidence of biliary obstruction and ERCP was normal. A liver biopsy showed intrahepatic cholestasis compatible with drug induced liver injury. He was treated with ursodiol (750 mg daily). Once pravastatin was stopped, symptoms and liver test abnormalities improved rapidly and were completely normal 7 weeks later.

#### Key Points

Medication: | Pravastatin (20 mg daily)
Pattern: | Mixed (R=2.8)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 6 weeks
Recovery: | ~7 weeks
Other medications: | Metoprolol

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin (mg/dL) | Other
6 weeks | 0 | 421 | 482 | 13.6 | Admission
| 2 days | 260 | | 11.8
8 weeks | 2 weeks | 151 | | 3.7
9 weeks | 3 weeks | 255 | | 3.0 | Liver biopsy
10 weeks | 4 weeks | 210 | | 1.9 | Discharge
3 months | 7 weeks | 40 | Normal | 0.5 | Outpatient follow up
Normal Values | | <40 | <130 | <1.2

* Some values estimated from Figure 1.

#### Comment

The onset of injury within 2 months of starting pravastatin and resolution within 2 months of stopping is supportive evidence that this represented drug induced liver disease due to pravastatin. All other causes of acute liver injury were satisfactorily excluded. Metoprolol had been used for a longer period and, like other beta-blockers, is a rare cause of drug induced liver injury. The pattern of serum enzyme elevations was considered “mixed” but the clinical presentation, symptoms and liver histology were more cholestatic. This patient had previously tolerated simvastatin without obvious liver injury. Cross susceptibility to cholestatic hepatitis from the statins is frequent but not invariable.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pravastatin – Generic, Pravachol®

DRUG CLASS

Antilipemic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=pravastatin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Pravastatin | 81093-37-0 | C23-H36-O7

## CITED REFERENCE

1 Hartleb M, Rymarczyk G, Januszewski K. (1999). Acute cholestatic hepatitis associated with pravastatin. Am J Gastroenterol.

## ANNOTATED BIBLIOGRAPHY

References updated: 01 December 2021

Abbreviations used: ANA, antinuclear antibody; HDL, high density lipoprotein; LDL, low density lipoprotein; OD, odds ratio.

Zimmerman HJ. Drugs used in the treatment of hypercholesterolemia and hyperlipidemia. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 660-2. (Expert review of hepatotoxicity published in 1999; the statins have dose related hepatic effects in guinea pigs and rabbits and transient elevations in aminotransferases occur in 1-5% of humans treated; several cases of clinically apparent liver injury from lovastatin and simvastatin have been published).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic medications. Lipid lowering agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 519-40. (Review of hepatotoxicity of lipid lowering agents; asymptomatic elevations in aminotransferases are common in patients receiving statins, but clinically significant hepatotoxicity is rare).
Gurgle H, Blumenthal DK. Drug therapy for dyslipidemias. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 605-618. (Textbook of pharmacology and therapeutics; “Serious hepatotoxicity is rare and unpredictable, with a rate of about 1 case per million person-years of use.” Multiple academic societies and the FDA recommend testing all patients for routine liver tests before starting statins but monitoring or retesting only if symptoms arise).
Ballarè M, Campanini M, Airoldi G, Zaccala G, Bertoncelli MC, Cornaglia G, Porzio M, et al. (1992). Hepatotoxicity of hydroxy-methyl-glutaryl-coenzyme A reductase inhibitors. Minerva Gastroenterol Dietol. (Prospective monitoring identified ALT elevations in 5% of 100 patients on simvastatin and 4.5% of 90 on pravastatin).
The Lovastatin Pravastatin Study Group. (1993). A multicenter comparative trial of lovastatin and pravastatin in the treatment of hypercholesterolemia. Am J Cardiol. (Controlled trial of lovastatin [20 to 80 mg] vs pravastatin [10 to 40 mg] daily for 18 weeks in 672 hypercholesterolemic patients; ALT elevations >3 times ULN occurred in 1 lovastatin and 2 pravastatin treated patients; no clinically apparent liver injury mentioned).
Morris R, Robinson G, Tilyard M, Gurr E. (1996). Pravastatin and risk factor modification in patients with moderate primary hypercholesterolaemia. NZ Med J. (In a prospective controlled trial in 78 patients, transient liver test abnormalities occurred in 3 patients on pravastatin [18%] and 7 [18%] on placebo; none led to discontinuation and none had symptoms or jaundice).
Hartleb M, Rymarczyk G, Januszewski K. (1999). Acute cholestatic hepatitis associated with pravastatin. Am J Gastroenterol. (57 year old man developed jaundice, 2 months after starting pravastatin [bilirubin 13.6 mg/dL, ALT 421 U/L, Alk P 482 U/L], resolving within 8 weeks of stopping: Case 1).
Heuer T, Gerards H, Pauw M, Gabbert HE, Reis HE. (2000). Med Klin (Munich). (4 patients with liver injury due to statins: 3 simvastatin and 1 pravastatin with jaundice arising 8-24 months after starting [bilirubin 1.9 to 7.4 mg/dL, ALT 39 to 841 U/L, Alk P 266 to 353], resolving within 3 months of stopping).
Punthakee Z, Scully LJ, Guindi MM, Ooi TC. (2001). Liver fibrosis attributed to lipid lowering medications: two cases. J Intern Med. (39 year old man developed fever and weakness 9 months after starting pravastatin [ALT ~500 U/L, but no jaundice], resolving rapidly with stopping and then recurring after 22 months of simvastatin therapy [ALT ~2800 U/L, ANA negative], biopsy showing chronic hepatitis whereas his enzymes remained normal over the next 6 years on no-statin therapy).
Hartleb M, Biernat L, Kochel A. (2002). Drug-induced liver damage--a three-year study of patients from one gastroenterological department. Med Sci Monit. (14 patients with drug induced liver injury seen in one hospital [Silesian Medical University] over 3 year period; due to amoxicillin/clavulanate in 3, antituberculosis agents 2, pravastatin 2, fluvastatin 1, and 6 other agents in 1 each; 2 pravastatin cases in 62 and 57 year olds with onset after 4 and 7 weeks [bilirubin 1.0 and 13.6 mg/dL, ALT 3.4 and 10.5 times ULN, Alk P 1.0 and 4.4 times ULN], one case with rapid recovery upon stopping and the other [with jaundice] protracted).
Batey RG, Harvey M. (2002). Cholestasis associated with the use of pravastatin sodium. Med J Aust. (64 year old woman developed abnormal liver tests 4 months after starting pravastatin [bilirubin 0.8 mg/dL, ALT 85 U/L, Alk P 362 U/L], improving on stopping and rising again with restarting, decreasing upon stopping but not to normal; never jaundiced or symptomatic).
Pfeffer MA, Keech A, Sacks FM, Cobbe SM, Tonkin A, Byington RP, Davis BR, et al. (2002). Safety and tolerability of pravastatin in long-term clinical trials: prospective Pravastatin Pooling (PPP) Project. Circulation. (Controlled trial of pravastatin vs placebo for 5 years in ~18,000 patients with hypercholesterolemia; no differences in rates of adverse events, gallstones in 1.9% vs 2.1% [pravastatin vs placebo], any abnormal ALT in 8.8% vs 8.2% and ALT >3 times ULN in 1.4% vs 1.3%).
Rosenson RS, Bays HE. (2003). Results of two clinical trials on the safety and efficacy of pravastatin 80 and 160 mg per day. Am J Cardiol. (Two placebo controlled trials of higher doses of pravastatin [40 and 160 mg/day for 6 weeks]; no ALT or AST elevations above 3 times the ULN in either study).
Parra JL, Reddy KR. (2003). Hepatotoxicity of hypolipidemic drugs. Clin Liver Dis. (Review and discussion of individual agents; rate of serum ALT elevations with pravastatin has been similar to that with placebo; mentions that single case report of cholestatic hepatitis due to pravastatin has appeared in the literature).
de Denus S, Spinler SA, Miller K, Peterson AM. (2004). Statins and liver toxicity: a meta-analysis. Pharmacotherapy. (Systematic review of 13 large controlled trials of statins with at least 48 weeks of therapy in 43,390 patients; overall odds ratio for liver test abnormalities with statins versus placebo was 1.26; lovastatin 1.78; simvastatin 1.06; pravastatin 1.00, and fluvastatin, 3.54).
Rallidis LS, Drakoulis CK, Parasi AS. (2004). Pravastatin in patients with nonalcoholic steatohepatitis: results of a pilot study. Atherosclerosis. (5 patients with nonalcoholic steatohepatitis were treated with pravastatin [20 mg daily for 6 months], ALT levels became normal in all five patients and histology improved in some, but not fibrosis scores).
Jacobson TA. (2004). Comparative pharmacokinetic interaction profiles of pravastatin, simvastatin, and atorvastatin when coadministered with cytochrome P450 inhibitors. Am J Cardiol. (Pharmacokinetic studies that demonstrate that drugs that inhibit CYP 3A4, the major P450 drug metabolizing enzyme [itraconazole, clarithromycin, verapamil], cause increases in blood levels of simvastatin and atorvastatin, but have little effect on pravastatin levels).
Nissen SE. (2005). Effect of intensive lipid lowering on progression of coronary atherosclerosis: evidence for an early benefit from the Reversal of Atherosclerosis with Aggressive Lipid Lowering (REVERSAL) trial. Am J Cardiol. (Controlled trial comparing pravastatin [40 mg] to atorvastatin [80 mg] daily for 18 months in 654 patients; ALT elevations >3 times ULN occurred in 1.6% on pravastatin vs 2.3% on atorvastatin, but no instances of clinically apparent hepatitis).
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, García-Ruiz E, García-Muñoz B, et al., Spanish Group for the Study of Drug-Induced Liver Disease. (2005). Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish registry over a 10-year period. Gastroenterology. (Among 461 cases of drug induced liver disease enrolled in a Spanish Registry between 1984 and 2004, 11 were attributed to statins, but no specific agent caused more than 4 cases).
Alsheikh-Ali AA, Karas RH. (2005). Adverse events with concomitant amiodarone and statin therapy. Prev Cardiol. (Review of MedWatch adverse event reports for proportion that included combination with amiodarone; 1.0% for simvastatin, 0.7% atorvastatin and 0.4% pravastatin; 77% had muscle and 30% liver involvement).
Conforti A, Magro L, Moretti U, Scotto S, Motola D, Salvo F, Ros B, et al. (2006). Fluvastatin and hepatic reactions: a signal from spontaneous reporting in Italy. Drug Safety. (Italian Pharmacovigilance Group review of 35,757 adverse reaction reports: 1260 due to statins of which 178 were hepatic; 69 [36%] fluvastatin, 37 [21%] atorvastatin, 50 [28%] simvastatin, 16 [9%] pravastatin, 6 [3%] rosuvastatin; proportion reporting rate based on number of prescriptions was highest for fluvastatin [~9] compared to other agents [~2-3]; 26 fluvastatin cases described as “hepatitis”, but no details given except that most cases occurred within 90 days of starting).
Law M, Rudnicka AR. (2006). Statin safety: a systematic review. Am J Cardiol. (Review of safety of statins; 38 cases of acute liver failure attributed to statins submitted to MedWatch by end of 1999, which gives an estimated rate of 1 per million person years of use; rate of confirmed ALT elevations >3 times ULN is 0.1% with statins and 0.04% with placebo).
Khorashadi S, Hasson NK, Cheung RC. (2006). Incidence of statin hepatotoxicity in patients with hepatitis C. Clin Gastroenterol Hepatol. (Electronic record review of rate of ALT elevations in patients with hepatitis C with or without statin therapy and controls on statin therapy found no differences between the three groups [20%, 24% and 17%]; severe abnormalities most frequent in patients with chronic hepatitis C not on statin [6.6% vs 1.2%]).
Silva MA, Swanson AC, Gandhi PJ, Tataronis GR. (2006). Statin-related adverse events: a meta-analysis. Clin Ther. (Metaanalysis of adverse event rates in 18 placebo controlled trials of six statins in 71,108 patients; ALT elevations >3 times ULN in 1.7% of statin vs 1.4% placebo recipients; event rates highest with atorvastatin, lowest with fluvastatin).
Dale KM, White CM, Henyan NN, Kluger J, Coleman CI. (2007). Impact of statin dosing intensity on transaminase and creatine kinase. Am J Med. (Metaanalysis of rates of ALT and CPK elevations in 9 controlled studies comparing low vs high doses of statins; ALT elevations >3 times ULN occurred in 1.5% of high- and 0.4% of low-intensity statin groups, effect particularly seen with hydrophilic [pravastatin and atorvastatin] compared to lipophilic agents [simvastatin and lovastatin]).
Alsheikh-Ali AA, Karas RH. (2007). Safety of lovastatin/extended release niacin compared with lovastatin alone, atorvastatin alone, pravastatin alone, and simvastatin alone (from the United States Food and Drug Administration adverse event reporting system). Am J Cardiol. (Analysis of MedWatch reports of adverse events found no excess in liver related adverse event reports per million prescription due to lovastatin alone [2.3] vs niacin alone [2.5] vs the combination [3.2], but slightly higher rates with atorvastatin [4.5], simvastatin [5.7] and pravastatin [4.9], but data relied upon spontaneous reporting).
Lewis JH, Mortensen ME, Zweig S, Fusco MJ, Medoff JR, Belder R, Pravastatin in Chronic Liver Disease Study Investigators. (2007). Efficacy and safety of high-dose pravastatin in hypercholesterolemic patients with well-compensated chronic liver disease: Results of a prospective, randomized, double-blind, placebo-controlled, multicenter trial. Hepatology. (Controlled trial of pravastatin [80 mg daily] vs placebo for 36 weeks in 326 patients with chronic liver disease and hypercholesterolemia [64% nonalcoholic steatohepatitis and 25% chronic hepatitis C]; cumulative incidence of ALT levels >twice baseline or ULN was 7.5% for pravastatin and 12.5% for placebo, and none had exacerbation of underlying liver disease or jaundice).
Contreras AM, Monteón FJ, Flores MR, Mendoza-Sánchez F, Ruiz I. (2007). Drug-related hepatotoxicity in a renal transplant recipient with long-term survival and hepatitis C. Ann Hepatol. (26 year old man with a renal transplant had ALT elevations [peak 151 U/L] without jaundice after several years of pravastatin therapy, which did not improve with stopping pravastatin or azathioprine, and later found to be due to chronic hepatitis C).
Bhardwah SS, Chalasani N. (2007). Lipid-lowering agents that cause drug-induced hepatotoxicity. Clin Liver Dis. (Review of hepatotoxicity of statins reported rates of ALT or AST elevations >3 times ULN: atorvastatin 0.7%, fluvastatin 1.2%, lovastatin 0.6%, pravastatin 1.4%, rosuvastatin 0% and simvastatin 1.8%. Abnormalities are usually asymptomatic, individual case reports of autoimmune hepatitis have been published).
Alsheikh-Ali AA, Maddukuri PV, Han H, Karas RH. (2007). Effect of the magnitude of lipid lowering on risk of elevated liver enzymes, rhabdomyolysis, and cancer: insights from large randomized statin trials. J Am Coll Cardiol. (Systematic review of relationship between LDL cholesterol lowering effects and adverse events in 23 statin treatment arms representing 309,506 person years of therapy; positive and graded relationship between statin dose [simvastatin, lovastatin and atorvastatin] and rates of ALT elevations, but no independent relationship to degree of LDL cholesterol decrease).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug-Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 3 cases were attributed to atorvastatin, 3 to simvastatin/ezetimibe, and one each to pravastatin, fluvastatin, and simvastatin, but most cases were mild or not clearly attributable to the statin therapy).
Martin JE, Cavanaugh TM, Trumbull L, Bass M, Weber F, Aranda-Michel J, Hanaway M, et al. (2008). Incidence of adverse events with HMG-CoA reductase inhibitors in liver transplant patients. Clin Transplant. (Retrospective review of adverse events associated with statin and fibrate use in 69 patients with liver transplants; myalgias problematic in 5, myopathy in 1, but none had significant ALT elevations or hepatitis related to medication).
Neuvonen PJ, Backman JT, Niemi M. (2008). Pharmacokinetic comparison of the potential over-the-counter statins simvastatin, lovastatin, fluvastatin and pravastatin. Clin Pharmacokinet. (Review of literature on pharmacokinetics of statins; simvastatin and lovastatin are metabolized extensively by the P450 system and levels are affected by inhibitors or inducers of CYP 3A4 [itraconazole, erythromycin, verapamil, diltiazem, cyclosporine], whereas fluvastatin and pravastatin are minimally if at all affected).
Russo MW, Scobey M, Bonkovsky HL. (2009). Drug-induced liver injury associated with statins. Semin Liver Dis. (Case reports and review of literature; 52 year old woman who developed fatigue 12 weeks after starting fluvastatin [bilirubin 1.2 mg/dL, ALT 850 U/L, Alk P 215 U/L, ANA negative], resolving on stopping fluvastatin, but recurring within 11 weeks of starting atorvastatin [bilirubin 1.0 rising to 12.5 mg/dL, ALT 1750 U/L, Alk P 285 U/L, ANA 1:160], responding to prednisone and azathioprine therapy).
Liu Y, Cheng Z, Ding L, Fang F, Cheng KA, Fang Q, Shi GP. (2010). Atorvastatin-induced acute elevation of hepatic enzymes and the absence of cross-toxicity of pravastatin. Int J Clin Pharmacol Ther. (Two men, ages 53 and 58, developed ALT elevations [peak 120 and 278 U/L] within a day of starting atorvastatin, resolving within 7 days of stopping and not recurring in either when pravastatin was started).
Hippisley-Cox J, Coupland C. (2010). Unintended effects of statins in men and women in England and Wales: population based cohort study using the QResearch database. BMJ. (Among 225,922 new users of statins in a UK health care database, there was an increased risk of moderate or severe liver dysfunction [ALT >3 times ULN], usually within first 6 months and associated with higher doses of statins; relative risks were highest with fluvastatin [2.53 in women, 1.97 in men] and lowest with pravastatin [0.93 to 1.58]).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 2 due to atorvastatin, 2 simvastatin and 2 cerivastatin, but none to pravastatin).
Björnsson E, Jacobsen EI, Kalaitzakis E. (2012). Hepatotoxicity associated with statins: reports of idiosyncratic liver injury post-marketing. J Hepatol. (Between 1988 and 2010, the Swedish registry received 217 adverse event reports possibly related to statins, 124 [57%] being liver related, 73 of which could be evaluated: 2 were fatal and one led to liver transplant; 3 had positive rechallenge; 43 [59%] were hepatocellular, 22 [30%] cholestatic and 8 [11%] mixed; 30 were due to atorvastatin, 28 simvastatin, 11 fluvastatin, 2 pravastatin and 2 rosuvastatin, arising after 30-248 days; atorvastatin injury was more likely to be cholestatic and was estimated to occur in 2.9 per 100,000 person years).
Farnier M, Marcereuil D, De Niet S, Ducobu J, Steinmetz A, Retterstøl K, Bryniarski L, et al. (2012). Safety of a fixed-dose combination of fenofibrate/pravastatin 160 mg/40 mg in patients with mixed hyperlipidaemia: a pooled analysis from a database of clinical trials. Clin Drug Investig. (Analysis of fixed combination of pravastatin with fenofibrate vs each alone in 5 large trials found no case of drug induced liver injury or rhabdomyolysis; elevations in ALT >3 times ULN occurred in 1.6% [2/122] on fenofibrate, 0.2% [1/519] on statins and 1.0% [16/1566] on the fixed combination, but all were transient and not accompanied by jaundice).
Sirtori CR, Mombelli G, Triolo M, Laaksonen R. (2012). Clinical response to statins: mechanism(s) of variable activity and adverse effects. Ann Med. (Review of the possible mechanisms for the beneficial and adverse effects of statins, including genetic variations in CYP enzymes, ABC transporters and HLA genes in causing adverse events, focused mostly upon myopathy and myalgias).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 2 attributed to atorvastatin and 1 to simvastatin, but none to pravastatin).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to statins or lipid lowering agents).
Russo MW, Hoofnagle JH, Gu J, Fontana RJ, Barnhart H, Kleiner DE, Chalasani N, et al. (2014). Spectrum of statin hepatotoxicity: Experience of the drug-induced liver injury network. Hepatology. (Among 1,188 cases of drug induced liver disease collected in the US between 2004 to 2012, 22 [2%] were attributed to statins, including atorvastatin [8], simvastatin [5], rosuvastatin [4], fluvastatin [2], pravastatin [2] and lovastatin [1]; median age was 60 years and 68% were women; 9 cases were cholestatic and 12 hepatocellular [6 with autoimmune features]; the latency ranged widely, from 1 month to 10 years; only one case was fatal [a man with preexisting cirrhosis presenting with acute-on-chronic liver failure]).
Bays H, Cohen DE, Chalasani N, Harrison SA. (2014). An assessment by the Statin Liver Safety Task Force: 2014 update. J Clin Lipidol. (Review of the safety of statins including their use in patients with liver disease recommending that liver tests be obtained before therapy, but that routine monitoring is not necessary and that statins can be safety used in patients with nonalcoholic liver disease, and are probably safe in other forms of chronic liver disease and after liver transplantation).
Ooba N, Sato T, Wakana A, Orii T, Kitamura M, Kokan A, Kurata H, et al. (2014). A prospective stratified case-cohort study on statins and multiple adverse events in Japan. PLoS One. (Among 6877 patients started on statins between 2008 and 2010, 139 developed an increase in ALT or AST deemed likely due to the drug with no significant differences among those treated with pra-, ator-, flu-, pita- or rosu-vastatin).
Macedo AF, Taylor FC, Casas JP, Adler A, Prieto-Merino D, Ebrahim S. (2014). Unintended effects of statins from observational studies in the general population: systematic review and meta-analysis. BMC Med. (Systematic review of 90 studies of 48 different "unintended effects" of statins with evidence of an increased risk of myopathy [Odds Ratio: OR=2.6] and raised liver enzymes [OR=1.5]).
(2014). Drugs for lipids. Treat Guidel Med Lett. (Concise recommendations on management of hyperlipidemia mentions that 1-2% of patients on high doses of statins develop ALT elevations [above 3 times ULN], but that there is not always cross sensitivity to this side effect and that patients with mild-to-moderate ALT elevations can tolerate statins; no discussion of clinically apparent liver).
Perdices EV, Medina-Cáliz I, Hernando S, Ortega A, Martín-Ocaña F, Navarro JM, Peláez G, et al. (2014). Hepatotoxicity associated with statin use: analysis of the cases included in the Spanish Hepatotoxicity Registry. Rev Esp Enferm Dig. (Among 858 cases of drug induced liver injury enrolled in a Spanish Registry between 1994 and 2012, 47 [5.5%] were attributed to statins [16 atorvastatin, 13 simvastatin, 12 fluvastatin, 4 lovastatin and 2 pravastatin], usually with a hepatocellular pattern of injury, 8.5% with autoimmune features, chronic injury in 19%, and no liver related deaths).
Chen GL, Hsiao FY, Dong YH, Shen LJ, Wu FL. (2014). Statins and the risk of liver injury: a population-based case-control study. Pharmacoepidemiol Drug Saf. (Among 2165 Taiwanese patients hospitalized for liver injury between 2002 and 2009, use of statins was not more frequent than among 16,600 hospitalized controls, except for use of high doses of rosuvastatin [adjusted odds ratio of 2.29]).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 31 cases [3.4%] were attributed to statins, including 8 to atorvastatin, 8 simvastatin, 7 rosuvastatin, 4 pravastatin, 2 fluvastatin and 2 lovastatin).
Carrascosa MF, Salcines-Caviedes JR, Lucena MI, Andrade RJ. (2015). Acute liver failure following atorvastatin dose escalation: is there a threshold dose for idiosyncratic hepatotoxicity?. J Hepatol. (85 year old woman on atorvastatin for more than a year developed jaundice after increasing dose from 40 to 80 mg daily [bilirubin 4.1 mg/dL, ALT 909 U/L, Alk P 415 U/L, CK 4753 U/L, INR 1.71], with transient worsening, but ultimate improvement and resolution).
Chang CH, Chang YC, Lee YC, Liu YC, Chuang LM, Lin JW. (2015). Severe hepatic injury associated with different statins in patients with chronic liver disease: a nationwide population-based cohort study. J Gastroenterol Hepatol. (Among 37,929 Taiwanese persons with chronic liver disease started on statin therapy for hyperlipidemia between 2005 and 2009, there were 912 incident cases of hospitalization for liver injury, rates being similar for the 6 different statins used [1.94-2.95 per 100,000 person-days], but higher in those on high doses of atorvastatin [40 or 80 mg daily]).
Kim HS, Lee SH, Kim H, Lee SH, Cho JH, Lee H, Yim HW, et al. (2016). Statin-related aminotransferase elevation according to baseline aminotransferases level in real practice in Korea. J Clin Pharm Ther. (Among 21,233 Korean patients starting statin therapy between 2009 and 2013, abnormal ALT or AST values above 3 times ULN were more frequent among those with mild baseline elevations).
Björnsson ES. (2017). Hepatotoxicity of statins and other lipid-lowering agents. Liver Int. (Review of the hepatotoxicity of statins mentions that atorvastatin has been the most frequently implicated statin [accounting for 30-40% of cases] in drug induced liver injury estimated to arise in 1 in 17,000 users, cholestatic in 56% and with autoimmune features in 10% and rarely fatal).
Wang LY, Huang YS, Perng CL, Huang B, Lin HC. (2016). Statin-induced liver injury in an area endemic for hepatitis B virus infection: risk factors and outcome analysis. Br J Clin Pharmacol. (Analysis of the Taipei Veterans Hospital database from 2008 to 2012 identified 108 patients with statin-associated liver injury [including 28 rosu-, 20 flu-, 17 sim-, 11 pra-, 8 lo-, and 8 pita-vastatin] most of which 75 [69%] were mild and only one fatal [80 year old on rosuvastatin], and there were no differences in disease features or peak enzyme or bilirubin levels between HBsAg positive vs negative subjects [n=16 vs 92]).
Giugliano RP, Wiviott SD, Blazing MA, De Ferrari GM, Park JG, Murphy SA, White JA, et al. (2017). Long-term safety and efficacy of achieving very low levels of low-density lipoprotein cholesterol: a prespecified analysis of the IMPROVE-IT Trial. JAMA Cardiol. (Among 15,281 patients recovering from an acute cardiac syndrome treated with simvastatin [40 mg daily] with or without ezetimibe for up to 6 years, 6.4% achieved very low LDL-cholesterol levels [<30 mg/dL] and subsequently had low rates of cardiovascular events, but also no increase in rates of adverse events from statins such including ALT elevations above 3 times ULN [2.2% vs 1.8-2.1%]).
Liang X, He Q, Zhao Q. (2018). Effect of stains on LDL reduction and liver safety: a systematic review and meta-analysis. Biomed Res Int. (In a systematic review of 16 controlled trials of statins in 74,078 patients, rates of liver test abnormalities were higher with statin therapy [odds ratio, OR=1.18] but this was significant only for fluvastatin [OR=3.5] and with higher doses [40-80 mg daily] [OD=3.6] and was not significant for statins used at low or moderate doses).
Yebyo HG, Aschmann HE, Kaufmann M, Puhan MA. (2019). Comparative effectiveness and safety of statins as a class and of specific statins for primary prevention of cardiovascular disease: A systematic review, meta-analysis, and network meta-analysis of randomized trials with 94,283 participants. Am Heart J. (Metaanalyses of 40 trials of statins that enrolled 94,283 patients followed for a median of 1 year for efficacy and safety reported that statins as a class increased the risk of hepatic dysfunction by 6% with fluvastatin having the highest relative risk).
(2019). Lipid-lowering drugs. Med Lett Drugs Ther. (Concise review of the mechanism of action, relative efficacy, safety and costs of lipid lowering drugs including statins, ezetimibe, PCSK9 inhibitors, bile acid sequestrants, fibric acid derivatives niacin and fish oil, mentions that statin therapy is associated with ALT elevations above 3 times ULN in 1-3% of patients but “whether statins actually cause liver damage is unclear”).
Simon TG. (2020). When less is more: dosing simvastatin in decompensated cirrhosis. Lancet Gastroenterol Hepatol. (Editorial in response to Pose et al [2020] discusses the possible beneficial effects of statins in patients with cirrhosis and the issue of increased rate of muscle toxicity with 40 vs to 20 mg daily).
Hopewell JC, Offer A, Haynes R, Bowman L, Li J, Chen F, Bulbulia R, et al. (2020). Independent risk factors for simvastatin-related myopathy and relevance to different types of muscle symptom. Eur Heart J. (In a combined analysis of 3 large clinical trials in patients with cardiovascular disease treated with simvastatin for a mean of 3.4 years, 171 of 58,390 participants [0.1%] developed myopathy [muscle pain and CK levels above 10 times ULN], and risk was higher with higher doses, in Asian subjects, women, and persons with higher BMI and multiple comorbidities as well as with SLCO1B1 genotype).
Balasubramanian R, Maideen NMP. (2021). HMG-CoA reductase inhibitors (statins) and their drug interactions involving CYP enzymes, P-glycoprotein and OATP transporters-an overview. Curr Drug Metab. (Systematic review of literature on drug-drug interactions with statins and their clinical significance mentions that toxicity can be enhanced by inhibitors of CYP3A4 [ator-, sim- and lo-vastatin] as well as by inhibitors of P glycoprotein and OATP1B1 [most statins including rosuvastatin] with specific recommendations for the most common inhibitors).
Sung S, Al-Karaghouli M, Kalainy S, Cabrera Garcia L, Abraldes JG. (2021). A systematic review on pharmacokinetics, cardiovascular outcomes and safety profiles of statins in cirrhosis. BMC Gastroenterol. (Systematic review of literature suggests that rosuvastatin and pitavastatin pharmacokinetics are unchanged in patients with Child’s Class A cirrhosis as opposed to atorvastatin and pravastatin, although unlike rosuvastatin, simvastatin, atorvastatin and pravastatin have been assessed in clinical trials in cirrhotic patients).
Cai T, Abel L, Langford O, Monaghan G, Aronson JK, Stevens RJ, Lay-Flurrie S, et al. (2021). Associations between statins and adverse events in primary prevention of cardiovascular disease: systematic review with pairwise, network, and dose-response meta-analyses. BMJ. (Systematic review of placebo controlled trials of statins for cardiovascular disease prevention identified 62 publications with 120,456 patients and found an increased risk of muscle symptoms, liver test abnormalities, renal insufficiency and eye conditions for all 7 statins, but not muscle disorders or diabetes; rosuvastatin having relatively high risk for muscle symptoms and renal abnormalities and also was also associated with eye conditions and diabetes while atorvastatin and lovastatin had highest risk for liver abnormalities).

## OTHER REFERENCE LINKS

1 Recent References on Pravastatin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=pravastatin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Pravastatin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=pravastatin)